# Nizatidine

## OVERVIEW

### Introduction

Nizatidine is a histamine type 2 receptor antagonist (H2 blocker) which is widely used for treatment of acid-peptic disease and heartburn. Nizatidine has been linked to rare instances of clinically apparent acute liver injury.

### Background

Nizatidine (nye za' ti deen) was the fourth histamine type 2 receptor blocker (H2 blocker) introduced into clinical practice in the United States and is a commonly used agent for treatment of duodenal and gastric ulcer and gastroesophageal reflux disease. Other H2 blockers in clinical use include cimetidine, ranitidine and famotidine. The H2 blockers are specific antagonists of the histamine type 2 receptor, which is found on the basolateral (antiluminal) membrane of gastric parietal cells. The binding of the agent to the H2 receptor results in inhibition of acid production and secretion, and improvement in symptoms and signs of acid-peptic disease. The H2 blockers inhibit an early, “upstream” step in gastric acid production and are less potent that the proton pump inhibitors, which inhibit the final common step in acid secretion. Nevertheless, the H2 blockers inhibit 24 hour gastric acid production by about 70% and are most effective in blocking basal and nocturnal acid production. Nizatidine was first approved for use in the United States in 1988 and is now available both by prescription and over-the-counter. The listed indications for nizatidine are duodenal and gastric ulcer disease, gastroesophageal reflux and prevention of stress ulcers. Nizatidine is available by prescription in capsules of 150 and 300 mg in several generic forms and in both oral and parenteral forms under the brand name Axid. Over-the-counter preparations of nizatidine are usually tablets of 75 mg (Axid-AR). Side effects are uncommon, usually minor, and include diarrhea, constipation, fatigue, drowsiness, headache and muscle aches.

### Hepatotoxicity

Chronic therapy with nizatidine and other H2 blockers is associated with minor elevations in serum aminotransferase levels in 1% to 4% of patients, but similar rates have been reported in placebo recipients. The ALT elevations are usually asymptomatic and transient and may resolve without dose modification. Rare instances of clinically apparent liver injury have been reported in patients receiving nizatidine, but too few cases have been reported to characterize a typical time to onset or pattern of injury. More information is available on the hepatotoxicity of other H2 blockers such as ranitidine and cimetidine which have been implicated in causing clinically apparent liver injury in 1:20,000 to 1:100,000 users. The time to onset of H2 blocker induced liver injury tends to be short, between 1 and 6 weeks of starting. The typical pattern of serum enzyme elevations varies from hepatocellular to cholestatic, most cases being “mixed”. The injury can be severe, but is typically mild-to- moderate in severity and self-limited in course, resolving within 4 to 12 weeks of stopping. Immunoallergic features (rash, fever, eosinophilia) are uncommon, as is autoantibody formation. Liver biopsy histology often shows centrolobular (zone 3) necrosis with mixed cellular infiltrates and mild cholestasis.

Likelihood score: D (possible rare cause of clinically apparent liver injury).

### Mechanism of Injury

Nizatidine is metabolized by the microsomal P450 drug metabolizing enzymes and injury may be the result of its activation to a toxic intermediate. Despite its metabolism by the P450 system, nizatidine does not result in significant inhibitor or induction of the enzymes and thus is less likely to cause drug-drug interactions than cimetidine.

### Outcome and Management

The hepatic injury caused by nizatidine is usually rapidly reversible with stopping the medication, but an instance of severe hepatitis with incomplete recovery and cirrhosis has been reported (Case 1). Nizatidine has been in use for a shorter time than cimetidine or ranitidine and remains unknown whether there is cross reactivity in hepatic injury between nizatidine and other H2 blockers. If acid suppression is required, use of an unrelated proton pump inhibitor is probably prudent for patients with clinically apparent nizatidine induced liver injury.

The H2 receptor blockers include cimetidine, famotidine, nizatidine, and ranitidine. General references on all four agents are given together after the overview section on H2 Blockers, while specific references are given for each drug. See also the Proton Pump Inhibitors.

Drug Class: Antiulcer Agents

Other Drugs in the Subclass, Histamine Type 2 Receptor Antagonists: Cimetidine, Famotidine, Ranitidine

## CASE REPORT

### Case 1. Severe acute liver injury leading to cirrhosis caused by nizatidine.

[Modified from: Chey WD, Kochman ML, Traber PG, Appelman HD, Gumucio JJ. Possible nizatidine-induced subfulminant hepatic failure. J Clin Gastroenterol 1995; 20: 164-7. PubMed Citation (https://www.ncbi.nlm.nih.gov/pubmed/7769203)]

A 39 year old man developed rash after 7 days and jaundice after 14 days of nizatidine therapy for dyspepsia. Despite the symptoms and jaundice, he continued nizatidine for a total of 28 days. One month after stopping he was still jaundiced and sought medical care. He denied a history of liver disease, exposure to viral hepatitis or recent excessive alcohol intake. He was taking no other medications and had no history of drug allergies. Laboratory testing revealed marked elevations in serum bilirubin, AST and alkaline phosphatase (Table). The prothrombin time was prolonged at 18.7 seconds. Abdominal ultrasound and computerized tomography showed no evidence of gallstones or biliary obstruction, and endoscopic retrograde pancreatocholangiography showed no abnormality of the extra- or intra-hepatic biliary system. Ten weeks after starting and 6 weeks after stopping nizatidine, he was hospitalized because of increasing fatigue, jaundice and abdominal swelling. On physical examination, he was deeply jaundiced and had mild asterixis and ascites. Tests for hepatitis A, B and C were negative and autoantibodies were not present. A liver biopsy showed massive multi-lobular necrosis without significant fibrosis. He was referred for liver transplantation, but was managed conservatively and slowly improved, allowing for discharge from the hospital after 19 days. While liver tests improved, they did not become completely normal, and one year later serum bilirubin, aminotransferases and alkaline phosphatase levels were still abnormal. Upper endoscopy revealed esophageal varices. A liver biopsy several months later revealed irregular, but relatively inactive cirrhosis.

#### Key Points

Medication: | Nizatidine (dose not provided)
Pattern: | Hepatocellular (R=8.8)
Severity: | 4+ (jaundice and signs of hepatic failure)
Latency: | 2 weeks to onset of jaundice, 8 weeks to laboratory confirmation
Recovery: | Incomplete
Other medications: | None mentioned

#### Laboratory Values

Time After Starting | Time After Stopping | ALT (U/L) | Alk P (U/L) | Bilirubin (mg/dL) | Other
| | Nizatidine given for 4 weeks
2 months | 1 month | 461 | 152 | 21.7 | Protime 18.7 sec
3.5 months | 2.5 months | 255 | 188 | 16.8 | Protime 20.0 sec
4 months | 3 months | 270 | 202 | 16.6 | Biopsy: massive necrosis
5 months | 4 months | 258 | 256 | 26.2 | Discharge
12 months | 11 months | 74 | 252 | 1.8 | Protime 13.4 sec
16 months | 15 months | | | | Biopsy: cirrhosis
Normal Values | | <40 | <115 | <1.2

#### Comment

This patient developed a severe hepatitis within a few weeks of starting nizatidine but continued taking the medication for two weeks after jaundice was noticed by his wife. He still delayed getting medical advice for another month after stopping nizatidine at which time he was deeply jaundiced and had signs of hepatic failure. When he developed ascites and hepatic encephalopathy, he was referred for liver transplant evaluation, but then began to improve spontaneously. He had a slow an incomplete recovery and was found to have cirrhosis on a liver biopsy done over a year later. Follow up is available from the authors. This patient has been followed at the transplant center from which this publication came for more than 15 years after this event and still has borderline hepatic decompensation, but has yet to require liver transplantation. No other source for the liver disease has been identified. Thus, cirrhosis induced by medications may not be completely reversible, but tends to be stable and nonprogressive as long as the medication is not restarted and other forms of hepatic injury (alcohol, hepatitis) are avoided.

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Nizatidine – Generic, Axid®

DRUG CLASS

Antiulcer Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Nizatidine)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Nizatidine | 76963-41-2 | C12-H21-N5-O2-S2 | Nizatidine Chemical Structure

## ANNOTATED BIBLIOGRAPHY

References updated: 25 January 2018

Zimmerman HJ. H2 Receptors antagonists. In, Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999, pp. 719-20. (Expert review of hepatotoxicity published in 1999 states that cimetidine and ranitidine, despite enormous use, have been implicated in a small number of cases of hepatic injury, 39 for cimetidine, 35 for ranitidine and only 1 for famotidine, all cases recovering and signs of hypersensitivity being rare).
Wallace JL, Sharkey KA. Pharmacotherapy of gastric acidity, peptic ulcers, and gastroesophageal reflux disease. In, Brunton LL, Chabner BA, Knollman BC, eds. Goodman & Gilman's the pharmacological basis of therapeutics. 12th ed. New York: McGraw-Hill, 2011, pp. 1309-22. (Textbook of pharmacology and therapeutics).
Black M. Hepatotoxic and hepatoprotective potential of histamine(H2)-receptor antagonists. Am J Med 1987; 83: 68-75. (Review of hepatotoxicity of cimetidine and ranitidine and their potential role in ameliorating acetaminophen hepatotoxicity, perhaps via their inhibition of P450 activity). 2892410
Cloud ML. Safety of nizatidine in clinical trials conducted in the USA and Europe. Scand J Gastroenterol Suppl 1987; 136: 29-36. (Analysis of clinical trials of nizatidine in 3800 patients; there were no drug related deaths and the most common side effects were headache, rhinitis, abdominal discomfort, diarrhea, and nausea, but none were more frequent than with placebo; ALT elevations >3 times ULN occurred in 1% of nizatidine- and 0.9% of placebo recipients; among 7 patients with marked liver test abnormalities, none were symptomatic and none were clearly related to nizatidine therapy). 2892253
Lewis JH. Hepatic effects of drugs used in the treatment of peptic ulcer disease. Am J Gastroenterol 1987; 82: 987-1003. (Thorough review of hepatotoxicity of antiulcer medications; 10 published cases of hepatotoxicity due to cimetidine and 12 for ranitidine, none fatal and not all convincingly due to the medication; little information available on famotidine or nizatidine). 2889354
Price AH, Brogden RN. Nizatidine. A preliminary review of its pharmacodynamic and pharmacokinetic properties, and its therapeutic use in peptic ulcer disease. Drugs 1988; 36: 521-39. (Review of pharmacology, clinical efficacy and side effects of nizatidine based upon 3800 patients in therapeutic trials; discontinuation for side effects was more common with placebo [6.5%] than nizatidine [2.5%], and common events occurred equally with placebo except for urticaria [0.5%], somnolence [2.4%] and sweating [1%]; low rates of ALT elevations, similar in placebo and ranitidine treated patients; no mention of hepatitis). 2905640
Chey WD, Kochman ML, Traber PG, Appelman HD, Gumucio JJ. Possible nizatidine-induced subfulminant hepatic failure. J Clin Gastroenterol 1995; 20: 164-7. (39 year old developed dyspepsia after 1 and jaundice after 2 weeks of nizatidine, not stopping until 4 weeks; 1 month later he was deeply jaundiced [bilirubin 21.7 mg/dL, AST 461 U/L, Alk P 152 U/L, prothrombin time 18.7 sec] and went on to have hepatic failure with ascites and encephalopathy, beginning to improve after referral for liver transplant; one year later he had varices and liver test abnormalities [bilirubin 1.8 mg/dL, ALT 98 U/L, Alk P 252 U/L], liver biopsies showing multilobular collapse acutely and inactive cirrhosis 16 months later: Case 1). 7769203
García Rodríguez LA, Ruigómez A, Jick H. A review of epidemiologic research on drug-induced acute liver injury using the general practice research data base in the United Kingdom. Pharmacotherapy 1997; 17: 721-8. (Combined analysis of 8 epidemiologic studies using the UK General Practice Research Database estimated incidence rates of acute liver injury to be highest for isoniazid and chlorpromazine [4 and 1.3 per 1000 users], intermediate for amoxicillin-clavulanate, cimetidine and ranitidine [2.3, 2.3 and 0.9 per 10,000] and lowest for trimethoprim/sulfamethoxazole, omeprazole, amoxicillin and nonsteroidals [5.2, 4.3, 3.9 and 3.7 per 100,000]). 9250549
García Rodríguez LA, Wallander MA, Stricker BH. The risk of acute liver injury associated with cimetidine and other acid-suppressing anti-ulcer drugs. Br J Clin Pharmacol 1997; 43: 183-8. (Case control study in cohort of 100,000 users of antiulcer drugs in a UK general practice database; 33 cases of acute liver injury found, 12 on cimetidine for a relative risk [RR] of 5.5, 1 on omeprazole and 5 on ranitidine did not raise RR above baseline. Latency was <2 months in 80% of cases; most antiulcer drug cases had hepatocellular or mixed enzyme patterns [15 of 18]). 9131951
Fisher AA, Le Couteur DG. Nephrotoxicity and hepatotoxicity of histamine H2 receptor antagonists. Drug Saf 2001; 24: 39-57. (Review of renal and hepatic complications of H2 blocker therapy). 11219486
Russo MW, Galanko JA, Shrestha R, Fried MW, Watkins P. Liver transplantation for acute liver failure from drug-induced liver injury in the United States. Liver Transpl 2004; 10: 1018-23. (Among ~50,000 liver transplants reported to UNOS between 1990 and 2002, 270 [0.5%] were done for drug induced acute liver failure, but none were attributed to an H2 blocker or proton pump inhibitor). 15390328
de Abajo FJ, Montero D, Madurga M, García Rodríguez LA. Acute and clinically relevant drug-induced liver injury: a population based case-control study. Br J Clin Pharmacol 2004; 58: 71-80. (Analysis of General Practice Research Database from UK on 1.6 million persons from 1994-2000 found 128 cases of drug induced liver injury [2.4/100,000 person years]; 3 cases were attributed to cimetidine for an odds ratio of 2.0 compared to controls [n=5000], which was not statistically significant; no mention of nitazidine). 15206996
Björnsson E, Jerlstad P, Bergqvist A, Olsson R. Fulminant drug-induced hepatic failure leading to death or liver transplantation in Sweden. Scand J Gastroenterol 2005; 40: 1095-101. (Survey of all cases of DILI with fatal outcome from Swedish Adverse Drug Reporting system from 1966-2002; 103 cases identified as highly probable, probable or possible, one case was attributed to ranitidine and one to omeprazole; none to nitazidine). 16165719
Sabaté M, Ibáñez L, Pérez E, Vidal X, Buti M, Xiol X, Mas A, et al. Risk of acute liver injury associated with the use of drugs: a multicentre population survey. Aliment Pharmacol Ther 2007; 25: 1401-9. (Population based survey of 126 cases of acute liver injury due to drugs between 1993-1999 in Spain; 8 were attributed to ranitidine alone [incidence 5.1/100,000 person-years] and 5 to omeprazole alone [2.1/100,000]; nitazidine not mentioned). 17539979
Chalasani N, Fontana RJ, Bonkovsky HL, Watkins PB, Davern T, Serrano J, Yang H, Rochon J; Drug Induced Liver Injury Network (DILIN). Causes, clinical features, and outcomes from a prospective study of drug-induced liver injury in the United States. Gastroenterology 2008; 135: 1924-34. (Among 300 cases of drug induced liver disease in the US collected between 2004 and 2008, 2 were attributed to ranitidine, none to cimetidine, nitazidine or omeprazole). 18955056
Ferrajolo C, Capuano A, Verhamme KM, Schuemie M, Rossi F, Stricker BH, Sturkenboom MC. Drug-induced hepatic injury in children: a case/non-case study of suspected adverse drug reactions in VigiBase. Br J Clin Pharmacol 2010; 70: 721-8. (Worldwide pharmacovigilance database contained 9036 hepatic adverse drug reactions in children, there were no antiulcer agents in the top 40 causes). 21039766
Reuben A, Koch DG, Lee WM; Acute Liver Failure Study Group. Drug-induced acute liver failure: results of a U.S. multicenter, prospective study. Hepatology 2010; 52: 2065-76. (Among 1198 patients with acute liver failure enrolled in a US prospective study between 1998 and 2007, 133 were attributed to drug induced liver injury, but none were due to H2 blockers or other antiulcer medications). 20949552
Björnsson ES, Bergmann OM, Björnsson HK, Kvaran RB, Olafsson S. Incidence, presentation and outcomes in patients with drug-induced liver injury in the general population of Iceland. Gastroenterology 2013; 144: 1419-25. (In a population based study of drug induced liver injury from Iceland, 96 cases were identified over a 2 year period, but none were attributed to cimetidine or other antiulcer medications). 23419359
Hernández N, Bessone F, Sánchez A, di Pace M, Brahm J, Zapata R, A Chirino R, et al. Profile of idiosyncratic drug induced liver injury in Latin America. An analysis of published reports. Ann Hepatol 2014; 13: 231-9. (Systematic review of literature of drug induced liver injury in Latin American countries published from 1996 to 2012 identified 176 cases, the most commonly implicated agents being nimesulide [n=53], cyproterone [n=18], nitrofurantoin [n=17] and antituberculosis drugs [n=13]; no case was linked to nizatidine or other antiulcer agent or H2 blocker). 24552865
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al.; United States Drug Induced Liver Injury Network. Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology 2015; 148: 1340-52.e7. (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, 6 cases were attributed to antiulcer medications, 3 to ranitidine and 3 to proton pump inhibitors, but none to nizatidine). 25754159

## OTHER REFERENCE LINKS

1. Recent References on Nizatidine: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(Nizatidine/AE)+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D%3A%222999/12/31%22%5BEDat%5D))
2. Trials on Nizatidine: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Nizatidine)